# Rifaximin

## OVERVIEW

### Introduction

Rifaximin is a nonabsorbable antibiotic that is used as treatment and prevention of travelers’ diarrhea and, in higher doses, for prevention of hepatic encephalopathy in patients with advanced liver disease and to treat diarrhea in patients with irritable bowel syndrome. Rifaximin has minimal oral absorption and has not been implicated in causing liver test abnormalities or clinically apparent liver injury.

### Background

Rifaximin (rif ax' i min) is a synthetic antibiotic and derivative of rifamycin specifically designed to have minimal gastrointestinal absorption (<0.4%). It is a broad spectrum antibiotic with activity against both aerobic and anaerobic organisms, both gram negative and gram positive. The antibiotic activity of rifaximin is attributed to its binding to bacterial RNA polymerases, preventing RNA and subsequent protein synthesis. Rifaximin was approved for use as treatment and means of preventing travelers’ diarrhea in 2004. In 2009, the indications were expanded to include prevention of hepatic encephalopathy in patients with cirrhosis and in 2015 to treat diarrhea in patients with irritable bowel syndrome. Rifaximin is available as tablets of 200 mg under the brand name of Xifaxan for traveler’s diarrhea (recommended dose being 200 mg thrice daily for 3 days) and as tablets of 550 mg under the brand name Xifaxan 550 for hepatic encephalopathy (recommended dose being 550 mg twice daily usually in combination with lactulose) and diarrhea-predominant irritable bowel syndrome (recommended dose being 550 mg 3 times daily for 14 days). Side effects include peripheral edema, nausea, dizziness, fatigue, muscle spasms and gastrointestinal upset. Long term use has been associated with fungal or bacterial super-infections including C. difficile associated diarrhea.

### Hepatotoxicity

Despite widespread use, there is little evidence that rifaximin when given orally causes liver injury, either in the form of serum enzyme elevations or clinically apparent liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Rifaximin has minimal systemic absorption and is unlikely to reach serum concentrations that might be hepatotoxic or induce CYP 3A4 enzyme activity or inhibit hepatic organic anion transport proteins, which the native compound has been shown to affect.

Other agents used for hepatic encephalopathy include neomycin and lactulose.

Drug Class: Antiinfective Agents; Gastrointestinal Agents, Antidiarrheals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rifaximin – Xifaxan®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=rifaximin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rifaximin | 80621-81-4 | C43-H51-N3-O11 | Rifaximin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 14 June 2018

Abbreviations: SBP, subacute bacterial peritonitis; IBS, irritable bowel syndrome.

Zimmerman HJ. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 598. (Expert review of hepatotoxicity published in 1999: rifamycin, but not rifaximin is discussed).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs; rif ampin can induce microsomal CYP enzymes as well as inhibit bilirubin update or excretion; rifaximin is not discussed).
Williams R, James OF, Warnes TW, Morgan MY. Evaluation of the efficacy and safety of rifaximin in the treatment of hepatic encephalopathy: a double-blind, randomized, dose-finding multi-centre study. Eur J Gastroenterol Hepatol 2000; 12: 203-8. (Controlled trial of 7 days of 3 doses of rifaximin in 54 patients with cirrhosis and hepatic encephalopathy found improvements in encephalopathy in all groups and no evidence of liver toxicity). 10741936
DuPont HL, Jiang ZD, Ericsson CD, Adachi JA, Mathewson JJ, DuPont MW, Palazzini E, et al. Rifaximin versus ciprofloxacin for the treatment of traveler's diarrhea: a randomized, double-blind clinical trial. Clin Infect Dis 2001; 33: 1807-15. (187 travelers to Mexico and Jamaica with diarrhea were randomized to receive rifaximin or ciprofloxacin for 3 days; both efficacy and adverse events were similar; no mention of ALT elevations or hepatotoxicity). 11692292
Rifaximin (Xifaxan) for travelers' diarrhea. Med Lett Drugs Ther 2004; 46: 74-5. (Concise review of the safety and efficacy of rifaximin for treating travelers' diarrhea shortly after its FDA approval). 15365508
DuPont HL, Jiang ZD, Okhuysen PC, Ericsson CD, de la Cabada FJ, Ke S, DuPont MW, et al. A randomized, double-blind, placebo-controlled trial of rifaximin to prevent travelers' diarrhea. Ann Intern Med 2005; 142: 805-12. (In a trial in 210 adult US student-travelers to Mexico randomized to take rifaximin or placebo for 2 weeks, there was a decrease in diarrheal illness with rifaximin [15% vs 54%]; there were no "clinically significant" patterns of laboratory abnormalities found). 15897530
Scarpignato C, Pelosini I. Rifaximin, a poorly absorbed antibiotic: pharmacology and clinical potential. Chemotherapy 2005; 51 Suppl 1: 36-66. (Review of the chemical structure, absorption, antibacterial activity and clinical efficacy and safety of rifaximin; when given orally it is nontoxic in experimental animals, and few adverse events have been reported in humans, most common being flatulence, nausea, vomiting and abdominal pain with rare cases of allergic rash, but no hepatotoxicity even in post-marketing studies). 15855748
Pimentel M, Park S, Mirocha J, Kane SV, Kong Y. The effect of a nonabsorbed oral antibiotic (rifaximin) on the symptoms of the irritable bowel syndrome: a randomized trial. Ann Intern Med 2006; 145: 557-63. (87 patients with irritable bowel syndrome were treated with rifaximin or placebo for 10 days; ALT levels and hepatotoxicity were not mentioned). 17043337
Taylor DN, Bourgeois AL, Ericsson CD, Steffen R, Jiang ZD, Halpern J, Haake R, et al. A randomized, double-blind, multicenter study of rifaximin compared with placebo and with ciprofloxacin in the treatment of travelers' diarrhea. Am J Trop Med Hyg 2006; 74: 1060-6. (399 US adult travelers to Mexico and India with diarrhea were treated with rifaximin, ciprofloxacin or placebo for 3 days; both agents were superior to placebo in shortening period of diarrhea with no differences in adverse events; hepatotoxicity and ALT levels were not mentioned). 16760520
Dupont HL, Jiang ZD, Belkind-Gerson J, Okhuysen PC, Ericsson CD, Ke S, Huang DB, et al. Treatment of travelers' diarrhea: randomized trial comparing rifaximin, rifaximin plus loperamide, and loperamide alone. Clin Gastroenterol Hepatol 2007; 5: 451-6. (310 US students in Mexico with diarrhea were randomized to receive rifaximin, loperamide or the combination for 3 days; rifaximin was more effective than loperamide and side effects were few; no mention of hepatotoxicity or ALT elevations). 17382603
Trehan I, Shulman RJ, Ou CN, Maleta K, Manary MJ. A randomized, double-blind, placebo-controlled trial of rifaximin, a nonabsorbable antibiotic, in the treatment of tropical enteropathy. Am J Gastroenterol 2009; 104: 2326-33. (144 Malawian 3 to 5 year old children were treated with rifaximin or placebo for 7 days, but no effect was found on urinary lactulose-to-mannitol ratio on a sugar absorption test [a measure of intestinal permeability]; side effects included diarrhea in 4% and rash in 4%; no mention of hepatotoxicity). 19491826
Layer P, Andresen V. Review article: rifaximin, a minimally absorbed oral antibacterial, for the treatment of travellers' diarrhoea. Aliment Pharmacol Ther 2010; 31: 1155-64. (Systematic review of literature on efficacy and safety of rifaximin in travelers' diarrhea; adverse events were reported in 24-27% of patients, but were generally mild and nonspecific and similar in frequency to placebo; no mention of hepatotoxicity). 20331580
Armstrong AW, Ulukan S, Weiner M, Mostafa M, Shaheen H, Nakhla I, Tribble DR, et al. A randomized, double-blind, placebo-controlled study evaluating the efficacy and safety of rifaximin for the prevention of travelers' diarrhea in US military personnel deployed to Incirlik Air Base, Incirlik, Turkey. J Travel Med 2010; 17: 392-4. (100 US soldiers were randomized to receive rifaximin or placebo for 14 days; travelers' diarrhea occurred in 6% of rifaximin and 15% of placebo recipients; adverse events were similar in the two groups; no mention of hepatotoxicity). 21050319
Bajaj JS, Riggio O. Drug therapy: rifaximin. Hepatology 2010; 52: 1484-8. (Review of the mechanism of action, efficacy and safety of rifaximin in the prevention of recurrent hepatic encephalopathy). 20814894
Bass NM, Mullen KD, Sanyal A, Poordad F, Neff G, Leevy CB, Sigal S, et al. Rifaximin treatment in hepatic encephalopathy. N Engl J Med 2010; 362: 1071-81. (299 patients with cirrhosis and a history of hepatic encephalopathy were randomized to receive rifaximin or placebo for 6 months; breakthrough episodes of encephalopathy were less common on rifaximin [22%] than placebo [46%]; adverse events were similar, but C. difficile occurred in two rifaximin-, but no placebo-treated patients). 20335583
Rifaximin (Xifaxan 550) for hepatic encephalopathy. Med Lett Drugs Ther 2010; 52: 87. (Concise review of rifaximin shortly after its approval for use in hepatic encephalopathy; while it reduces the rate of encephalopathy recurrence in patients with cirrhosis, it is expensive and its safety in patients with the most severe disease has not been established). 21045761
Flores J, Dupont HL, Jiang ZD, Okhuysen PC, Melendez-Romero JH, Gonzalez-Estrada A, Carrillo I, et al. A randomized, double-blind, pilot study of rifaximin 550 mg versus placebo in the prevention of travelers' diarrhea in Mexico during the dry season. J Travel Med 2011; 18: 333-6. (Among 98 US travelers to Mexico treated with rifaximin [550 mg once daily] or placebo for 14 days, travelers diarrhea occurred in similar proportions of both groups [22% vs 29%]; side effects were uncommon, but one placebo recipient developed mild jaundice [bilirubin 2.7 mg/dL, AST 46 U/L], with no further details provided). 21896097
Pimentel M, Lembo A, Chey WD, Zakko S, Ringel Y, Yu J, Mareya SM, et al.; TARGET Study Group. Rifaximin therapy for patients with irritable bowel syndrome without constipation. N Engl J Med 2011; 364: 22-32. (Among 1260 patients with irritable bowel syndrome [IBS] without constipation who were treated in two controlled trials of rifaximin vs placebo for 2 weeks, relief of symptoms was more frequent with rifaximin [41% vs 32%] while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 21208106
Prantera C, Lochs H, Grimaldi M, Danese S, Scribano ML, Gionchetti P; Retic Study Group (Rifaximin-Eir Treatment in Crohn's Disease). Rifaximin-extended intestinal release induces remission in patients with moderately active Crohn's disease. Gastroenterology 2012; 142: 473-81. (Controlled trial of 3 doses of rifaximin twice daily vs placebo for 12 weeks in 402 patients with Crohn disease; one case of C. difficile, but "no clinically signficant changes in results of safety laboratory tests were observed"). 22155172
Cremonini F, Lembo A. Rifaximin for the treatment of irritable bowel syndrome. Expert Opin Pharmacother 2012; 13: 433-40. ( Review of the evidence for efficacy and safety of rifaximin in IBS; "no significant adverse events have been reported during the clinical trials of rifaximin peformed to date in IBS"). 22251066
Sharma BC, Sharma P, Lunia MK, Srivastava S, Goyal R, Sarin SK. A randomized, double-blind, controlled trial comparing rifaximin plus lactulose with lactulose alone in treatment of overt hepatic encephalopathy. Am J Gastroenterol 2013; 108: 1458-63. (Among 120 patients with cirrhosis treated with lactulose with or without rifaximin, hospital stays were shorter and survival was better in those receiving rifaximin; no evidence of hepatotoxicity). 23877348
Mullen KD, Sanyal AJ, Bass NM, Poordad FF, Sheikh MY, Frederick RT, Bortey E, Forbes WP. Rifaximin is safe and well tolerated for long-term maintenance of remission from overt hepatic encephalopathy. Clin Gastroenterol Hepatol 2014; 12: 1390-7. (Among 392 patients with cirrhosis and hepatic encephalopathy treated with rifaximin [550 mg twice daily] for up to 24 months, adverse event rates were low and similar to historical controls; no mention of hepatotoxicity). 24365449
Schoenfeld P, Pimentel M, Chang L, Lembo A, Chey WD, Yu J, Paterson C, et al. Safety and tolerability of rifaximin for the treatment of irritable bowel syndrome without constipation: a pooled analysis of randomised, double-blind, placebo-controlled trials. Aliment Pharmacol Ther 2014; 39: 1161-8. (In a pooled analysis of 1932 patinets with IBS without constipation who were treated with rifaximin or placebo for 2 weeks, adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 24697851
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to rifaximin or other drugs used for hepatic encephalopathy or IBS). 25754159
Lembo A, Pimentel M, Rao SS, Schoenfeld P, Cash B, Weinstock LB, Paterson C, et al. Repeat treatment with rifaximin is safe and effective in patients with diarrhea-predominant irritable bowel syndrome. Gastroenterology 2016; 151: 1113-21. (Among 636 patients with diarrhea-predominant IBS who responded but then relapsed after therapy with rifaximin and who were then retreated with rifaximin or placebo, response rates were again higher with rifaximin while adverse event rates were similar, ALT elevations occurring in 2.1% of rifaximin vs 1.3% of placebo recipients). 27528177
Elfert A, Abo Ali L, Soliman S, Ibrahim S, Abd-Elsalam S. Randomized-controlled trial of rifaximin versus norfloxacin for secondary prophylaxis of spontaneous bacterial peritonitis. Eur J Gastroenterol Hepatol 2016; 28: 1450-4. (Among 262 patients with cirrhosis, ascites and history of spontaneous bacterial peritonitis [SBP] who were given prophylaxis with rifaximin or norfloxacin, SBP rates were lower with rifaximin [4% vs 14%] as was the mortality rate [14% vs 24%], while adverse event rates were lower [15% vs 36%]). 27512927
Suzuki K, Endo R, Takikawa Y, Moriyasu F, Aoyagi Y, Moriwaki H, Terai S, et al. Efficacy and safety of rifaximin in Japanese patients with hepatic encephalopathy: A phase II/III, multicenter, randomized, evaluator-blinded, active-controlled trial and a phase III, multicenter, open trial. Hepatol Res 2018; 48: 411-23. (Among 172 Japanese patients with cirrhosis and hepatic encephalopathy who were treated with rifaximin or lactitol for 2 weeks, response rates were similar in the 2 groups, but adverse event rates were lower with rifaximin; no mention of ALT levels or hepatotoxicity).29235218

## OTHER REFERENCE LINKS

1. Recent References on Rifaximin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rifaximin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rifaximin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rifaximin)